# Remimazolam

## OVERVIEW

### Introduction

Remimazolam is an ultra-short acting benzodiazepine used intravenously for induction and maintenance of sedation for adults undergoing short term procedures not requiring general anesthesia. Remimazolam sedation has not been associated with serum aminotransferase elevations and has not been linked to cases of clinically apparent liver injury.

### Background

Remimazolam (rem” a maz' oh lam) is a unique benzodiazepine with a rapid onset and ultra-short duration of action that is used for sedation for short term procedures that do not require general anesthesia. The sedative activity of the benzodiazepines is mediated by their ability to enhance gamma-aminobutyric acid (GABA) mediated inhibition of synaptic transmission through binding to the GABA A receptor. Remimazolam is a unique benzodiazepine in having a carboxylic ester in its chemical structure that is rapidly cleaved by tissue esterases accounting for its short half-life (0.6 to 0.9 hours compared to 1.8 to 6.4 hours for midazolam). Remimazolam was approved for induction and maintenance of sedation in adults for short term procedures not requiring general anesthesia. Remimazolam is available under the brand name Byfavo in lyophilized powder for reconstitution. The typical dose is 5 mg given over 1 minute which can be supplemented with doses of 2.5 mg in intervals of 2 minutes as needed. Common side effects of the use of intravenous remimazolam include hypotension, hypertension, bradycardia, and tachycardia. Less common adverse events include nausea, confusion, and acute agitation. Rare but potentially severe adverse events include severe respiratory depression and hypersensitivity reactions in patients with allergy to dextran. Acute overdose of remimazolam can cause respiratory arrest and death.

### Hepatotoxicity

Remimazolam, like other intravenously administered benzodiazepines, has not been associated with serum ALT elevations and no instances of clinically apparent liver injury from remimazolam have been reported. Rare cases of clinically apparent liver injury have been reported with oral benzodiazepines including alprazolam, chlordiazepoxide, clonazepam, diazepam, flurazepam and triazolam. The clinical pattern of acute liver injury from benzodiazepines usually arises only after 1 to 6 months of continuous or intermittent therapy and the pattern of injury is typically cholestatic. The injury from benzodiazepine is usually mild-to-moderate in severity. Fever and rash are uncommon as is autoantibody formation.

Likelihood score: E (unlikely cause of clinically apparent liver injury).

### Mechanism of Injury

Remimazolam has a carboxylic ester in its chemical structure that is rapidly cleaved by tissue esterases resulting in a short half-life. As a consequence it has minimal hepatic metabolism and no effect on CYP enzymes. Remimazolam does not appear to have clinically significant drug-drug interactions. The absence of liver injury is perhaps due to its rapid, non-hepatic metabolism and the short duration of therapy and low doses used.

### Outcome and Management

The case reports of hepatic injury due to benzodiazepines were followed by prompt and complete recovery upon stopping the medication, without evidence of residual or chronic injury. No cases of acute liver injury, cholestatic hepatitis, acute liver failure or chronic liver injury due to remimazolam have been described in the literature. There is no information about cross sensitivity to hepatic injury with other benzodiazepines, but such cross sensitivity is unlikely.

Drug Class: Sedatives and Hypnotics, Benzodiazepines

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Remimazolam – Byfavo®

DRUG CLASS

Sedatives and Hypnotics

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Remimazolam)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Remimazolam | 1001415-66-2 | C21-H19-Br-N4-O2

## ANNOTATED BIBLIOGRAPHY

References updated: 22 June 2023

Zimmerman HJ. Benzodiazepines. Psychotropic and anticonvulsant agents. In, Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999, pp. 491-3. (Expert review of benzodiazepines and liver injury published in 1999; mentions rare instances of cholestatic hepatitis have been reported due to alprazolam, chlordiazepoxide, diazepam, flurazepam, and triazolam, and hepatocellular injury with clorazepate and clotiazepam, but no reports of hepatic injury with lorazepam, oxazepam or temazepam; does not mention remimazolam).
Larrey D, Ripault MP. Benzodiazepines. Hepatotoxicity of psychotropic drugs and drugs of abuse. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013, pp. 455. (Review of benzodiazepine induced liver injury mentions that increases in liver enzymes during therapy are rare and significant hepatotoxicity uncommon; only a few cases [usually cholestatic] have been reported with alprazolam, chlordiazepoxide, diazepam, flurazepam and triazolam).
Mihic SJ, Mayfield J, Harris RA. Hypnotics and sedatives. In, Brunton LL, Hilal-Dandan R, Knollman BC, eds. Goodman & Gilman’s the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, pp. 339-53. (Textbook of pharmacology and therapeutics).
FDA. https://www.accessdata.fda.gov/drugsatfda_docs/nda/2020/212295Orig1s000MedR.pdf (FDA website with product labels and the integrated review of the efficacy and safety of remimazolam that supported its approval for use as procedural sedation mentions that serum levels of ALT, AST, alkaline phosphatase and bilirubin actually decreased through day 4 after remimazolam therapy; no mention of hepatotoxicity).
Björnsson E. Hepatotoxicity associated with antiepileptic drugs. Acta Neurol Scand 2008; 118: 281-90. (Review of hepatotoxicity of all anticonvulsants focusing upon phenytoin, valproate, carbamazepine; “Furthermore, hepatoxicity has not been convincingly shown to be associated with the use of benzodiazepines”). 18341684
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al.; United States Drug Induced Liver Injury Network. Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology 2015; 148: 1340-1352.e7. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, no cases were attributed to midazolam or any other benzodiazepine). 25754159
Rex DK, Bhandari R, Desta T, DeMicco MP, Schaeffer C, Etzkorn K, Barish CF, et al. A phase III study evaluating the efficacy and safety of remimazolam (CNS 7056) compared with placebo and midazolam in patients undergoing colonoscopy. Gastrointest Endosc. 2018;88:427-437.e6. (Among 461 adults undergoing colonoscopy who received remimazolam, midazolam or placebo as a procedural sedative after a single dose of fentanyl, adequate sedation was achieved more frequently with remimazolam and onset after starting and recovery of full alertness after stopping was more rapid with remimazolam, with similar rates of adverse events and no serious adverse event). 29723512
Pastis NJ, Yarmus LB, Schippers F, Ostroff R, Chen A, Akulian J, Wahidi M, et al.; PAION Investigators. Safety and efficacy of remimazolam compared with placebo and midazolam for moderate sedation during bronchoscopy. Chest. 2019;155:137-146. (Among 446 patients undergoing bronchoscopy who received procedural sedation with remimazolam, midazolam or placebo, the onset of adequate sedation was faster with remimazolam than midazolam and time to being fully alert was more rapid after stopping, while total and severe adverse event rates were similar in the three groups and success rates in completing the procedure were similar; no mention of ALT elevations or hepatotoxicity). 30292760
Stöhr T, Colin PJ, Ossig J, Pesic M, Borkett K, Winkle P, Struys MMRF, et al. Pharmacokinetic properties of remimazolam in subjects with hepatic or renal impairment. Br J Anaesth. 2021;127:415-423. (Pharmacokinetic studies in patients with liver dysfunction found a 38% decrease in rate of clearance of remimazolam resulting in prolonged sedative effect, averaging 8 minutes in healthy, 12 minutes for moderate and 16.7 minutes for severe hepatic impairment). 34246461
Rex DK, Bhandari R, Lorch DG, Meyers M, Schippers F, Bernstein D. Safety and efficacy of remimazolam in high risk colonoscopy: A randomized trial. Dig Liver Dis. 2021;53:94-101. (Among 77 patients at high risk for anesthesia who underwent colonoscopy who received remimazolam, midazolam or placebo sedation, remimazolam led to a more rapid onset of adequate sedation and a more rapid return to being fully alert, while adverse event rates were similar in the 3 groups and there was no mention of ALT elevations or hepatotoxicity). 33243567
Remimazolam (Byfavo) for short-term procedural sedation. Med Lett Drugs Ther. 2022;64(1644):26-28. (Concise review of the mechanism of action, clinical efficacy, safety, and cost of remimazolam, an ultrashort acting intravenous benzodiazepine, mentions adverse events of hypotension, hypertension, bradycardia, tachycardia, and dextran hypersensitivity reaction). 35171895

## OTHER REFERENCE LINKS

1 Recent References on Remimazolam: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(Remimazolam/AE)+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))
2 Trials on Remimazolam: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Remimazolam)